# Aclidinium

## OVERVIEW

### Introduction

Aclidinium is a synthetic anticholinergic agent that is used as an inhalant for treatment of acute bronchospasm due to chronic bronchitis or emphysema. Aclidinium has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Aclidinium (a" kli din' ee um) is a synthetic quaternary ammonium anticholinergic which inhibits the muscarinic actions of acetylcholine on autonomic nerve endings, decreasing bronchial smooth muscle contractions and alleviating bronchospasm in patients with chronic obstructive pulmonary disease (COPD). Aclidinium has potent activity against muscarinic acetylcholine type 3 (M3) receptors which are found in bronchial smooth muscle. Aclidinium is rapidly hydrolyzed in plasma, so that any actively absorbed drug is unlikely to cause major systemic side effects. Its quaternary ammonium structure also decreases its ability to cross lipid membranes such as the blood brain barrier. Aclidinium was approved for use in the United States in 2012 as a respiratory inhalant and indications include maintenance treatment of bronchospasm associated with chronic bronchitis and emphysema. Aclidinium is available in a dry powder inhaler under the brand name Tudorza Pressair. The typically recommended dose in adults is 1 inhalation (400 mcg) twice daily. The common side effects of typical anticholinergic agents (such as dryness of the mouth and eyes, decreased sweating, visual blurring, constipation, urinary retention, impotence, tachycardia and palpitations, anxiety and restlessness) are uncommon in patients treated with aclidinium by inhaler. Aclidinium use can cause paradoxical bronchospasm. Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

Likehood score: E (unlikely cause of clinically apparent liver injury).

### Hepatotoxicity

Like other anticholinergic agents, aclidinium has not been linked to episodes of liver enzyme elevations or clinically apparent liver injury. A major reason for its safety may relate to the low systemic absorption and exposure associated with anticholinergic agents administered by inhaler.

References on the safety and potential hepatotoxicity of anticholinergics are given together after the Overview section on the Anticholinergic Agents.

Drug Class: Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Aclidinium – Tudorza Pressair®

DRUG CLASS

Anticholinergic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Aclidinium)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Aclidinium | 320345-99-1 | C26H30NO4S2.Br | Aclidinium Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Aclidinium: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Aclidinium/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Aclidinium: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Aclidinium)